# Cholestyramine

## OVERVIEW

### Introduction

Cholestyramine is a nonabsorbed bile acid sequestrant that is used a therapy of hyperlipidemia and for the pruritus of chronic liver disease and biliary obstruction. Cholestyramine has been associated with mild and transient serum enzyme elevations during therapy, but has not been linked to cases of clinically apparent liver injury with jaundice.

### Background

Cholestyramine (koe" le stye' ra meen) is a large, highly positively charged anion exchange resin that binds to negatively charged anions such as bile acids (as well as other organic compounds and some medications). The binding of bile acids to cholestyramine creates an insoluble compound that cannot be reabsorbed and is thus excreted in the feces. Bile acids ordinarily undergo extensive (>95%) enterohepatic recirculation, being secreted in bile, acting as fat solubilizing compounds in the upper intestine, and then being reabsorbed in the distal small bowel. Chronic loss of bile acids from cholestyramine use results in a contraction of the total bile acid pool. The liver compensates for this decrease by increasing bile acid synthesis, which directly competes with cholesterol synthesis resulting in a decrease in serum levels. In addition, cholestyramine may also decrease in serum cholesterol by direct inhibition of fat absorption caused by its binding to bile acids in the intestine. Cholestyramine was approved for use in the United States in 1973 and is one of the oldest and safest cholesterol lowering agents, but it is currently used largely as an adjunctive therapy when statins or other lipid lowering agents result in an inadequate decrease in cholesterol levels. Cholestyramine is also effective in reducing the pruritus of chronic liver disease, probably as a function of binding the “pruritogen” in the intestine (which is either a bile acid or an organic anion like a bile acid that undergoes enterohepatic circulation). Because cholestyramine binds to negatively charged molecules, it can also be used to reduce absorption of medications taken in toxic overdoses and has multiple drug-drug interactions. Cholestyramine is available in multiple generic forms and under the brand name of Questran as a powder or in single dose packet form, generally in 4 gram amounts. The usual dose of cholestyramine is 4 grams, given one to six times per day usually before meals and at bedtime. Other drugs should be given 1 hour before or 4 to 6 hours after cholestyramine. Cholestyramine is unpalatable and can be difficult to swallow. Side effects include abdominal discomfort, indigestion, nausea, flatulence and constipation.

### Hepatotoxicity

There is little evidence that cholestyramine causes significant liver injury. However, mild elevations in serum aminotransferase levels occur in a proportion of patients on cholestyramine. The elevations have been mild, transient and without accompanying symptoms or jaundice. In one prospective study, cholestyramine therapy was associated with serum ALT elevations above 3 times the upper limit of normal in 11% of subjects. In all cases, the abnormalities were asymptomatic and resolved rapidly upon stopping cholestyramine. Serum alkaline phosphatase levels are usually normal. A single case report of marked serum aminotransferase elevations on bile acid sequestrant therapy with rapid resolution on stopping has been published. However, there have been no reports of clinically apparent liver injury with jaundice attributed to cholestyramine or the other bile acid sequestrants. Cholestyramine is used in patients with liver disease to treat pruritus, and has little or no effect on serum enzyme or bilirubin levels.

Likelihood score: E (unlikely cause of clinically apparent liver injury with jaundice).

### Mechanism of Injury

The mechanism by which cholestyramine causes serum aminotransferase elevations is not known. Because cholestyramine is not absorbed, it is surprising that it might cause liver injury, even mild and asymptomatic serum enzyme elevations. There is also little evidence that the contraction of the bile acid pool caused by its use harms the liver. Because cholestyramine can interfere with the absorption of other medications or vitamins, it may affect the levels of medications used for liver disease. These effects are particularly important for vitamins A, D, E, K, hormones such as estrogens, corticosteroids, and thyroid hormone, and medications such as thiazide diuretics, acetaminophen and digoxin.

References on the safety and hepatotoxicity of cholestyramine are given with those for colesevelam and colestipol in the Overview section on Bile Acid Resins/Sequestrants.

Drug Class: Antilipemic Agents, Bile Acid Resins/Sequestrants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cholestyramine – Generic, Questran®

DRUG CLASS

Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=cholestyramine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cholestyramine | 11041-12-6 | Unspecified | Cholestyramine chemical structure

## OTHER REFERENCE LINKS

1. Recent References on Cholestyramine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=cholestyramine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cholestyramine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=cholestyramine)